# Alpha Lipoic Acid

## OVERVIEW

### Introduction

Alpha lipoic acid is a natural occurring essential fatty acid that is synthesized intracellularly, but is also in many foods and absorbed to a variable extent. Alpha lipoic acid is a common ingredient in multivitamin tablets and in dietary supplements and is even included in many pet foods. While purported to have antioxidant, antidiabetic, and antiaging effects, it has not been approved by the FDA as therapy for any medical disease or condition. Alpha lipoic acid has been evaluated in many clinical trials and has not been associated with serum aminotransferase elevations or in cases of clinically apparent liver injury.

### Background

Alpha lipoic acid is a natural occurring fatty acid that serves as a necessary, covalently-bound cofactor in many enzymatic processes including the alpha ketoacid dehydrogenases that play a critical role in mitochondria in energy metabolism. Adequate amounts of alpha lipoic acid are synthesized in mitochondria from octanoic acid, but the natural dithiol fatty acid is also found in many foods and can be absorbed from the intestines and taken up in many organs and tissues including liver, kidney, and brain. Alpha lipoic acid has been purported to have antioxidant activity in scavenging free radicals and restoring glutathione levels, as well as antidiabetes activities in normalizing glucose and insulin activity, and as chelating metals. While these pharmacological actions have been found in vitro and in vivo, it is not clear whether alpha lipoic acid supplements have clinically meaningful actions in humans. Multiple studies of alpha lipoic acid in patients with diabetic polyneuropathy, arthritis, diabetes, fibromyalgia, multiple sclerosis, osteoarthritis and other conditions have yielded variable results, but almost invariably with minimal or no adverse side effects. While available in many forms over-the-counter, alpha lipoic acid has not been approved for use by the FDA for any medical disease or condition. In placebo controlled clinical trials in patients with diabetes and peripheral neuropathy, alpha lipoic acid was associated with mild improvements in surrogate markers of neuropathy but was not shown to ameliorate symptoms or progression of neuropathy. Currently, alpha lipoic acid is available in tablets and capsules of 50 to 600 mg and the recommended dosage has ranged from 100 to 600 mg once or twice daily. Alpha lipoic acid is usually well tolerated but side effects at higher doses can include abdominal discomfort, heartburn, constipation or diarrhea, nausea, dizziness, and headache. Rare, potentially severe adverse effects reported after single large overdoses include confusion, stupor, seizures, lactic acidosis, rhabdomyolysis, coma, and multiorgan failure that can be fatal.

### Hepatotoxicity

In multiple, largely short term clinical studies of different preparations and concentrations of alpha lipoic acid, adverse side effects were usually described as uncommon and minimal with either no change or slight improvement in serum aminotransferase levels. Despite widespread use, there have been no published reports of serum enzyme elevations or clinically apparent liver injury attributable to alpha lipoic acid given in conventional doses. In cases of overdose of alpha lipoic acid, some patients have developed lactic acidosis, hemodynamic instability, rhabdomyolysis, renal dysfunction, and multiorgan failure, but symptoms of neurologic, cardiac and renal dysfunction generally predominate and liver injury may be the result of shock and ischemia.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which alpha lipoic acid might cause liver injury is unknown. In cases of overdose with seizures and lactic acidosis, clinical features suggest that there is generalized mitochondrial failure predominantly affecting the central nervous system, heart, and muscle. The liver histology associated with alpha lipoic acid overdose has not been described but dogs given high doses develop hepatic abnormalities.

### Outcome and Management

Hepatotoxicity from alpha lipoic acid has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: ALA, Thioctic acid.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alpha Lipoic Acid – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/767.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Alpha Lipoic Acid (R) | 1200-22-2 | C8-H14-O2-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 3 May 2023

Abbreviations: ALA, alpha lipoic acid; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not alpha lipoic acid [ALA]).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of alpha lipoic acid).
Alpha lipoic acid. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 935-7. (Compilation of short monographs on herbal medications and dietary supplements).
Ziegler D, Hanefeld M, Ruhnau KJ, Meissner HP, Lobisch M, Schütte K, Gries FA. (1995). Treatment of symptomatic diabetic peripheral neuropathy with the anti-oxidant alpha-lipoic acid. A 3-week multicentre randomized controlled trial (ALADIN Study). Diabetologia. (Among 328 patients with diabetic peripheral neuropathy treated with ALA [100, 600, or 1200 mg] or placebo intravenously 4 to 5 days per week for 3 weeks, total neuropathy symptom scores improved by 43%, 63% and 58% with ALA vs 38% with placebo, while adverse events were similar with the lower doses as with placebo [14% and 18% vs 21%] but higher with the highest dose [33%]; no mention of ALT levels or hepatotoxicity).
Ziegler D, Schatz H, Conrad F, Gries FA, Ulrich H, Reichel G. (1997). Effects of treatment with the antioxidant alpha-lipoic acid on cardiac autonomic neuropathy in NIDDM patients. A 4-month randomized controlled multicenter trial (DEKAN Study). Deutsche Kardiale Autonome Neuropathie. Diabetes Care. (Among 73 patients with diabetic cardiac autonomic neuropathy treated with alpha lipoic acid [ALA: 800 mg] or placebo daily for 4 months, there was ultimately no difference in change in symptoms of autonomic neuropathy although changes in heart rate variability suggested a mild effect; there were no significant adverse events).
Ziegler D, Hanefeld M, Ruhnau KJ, Hasche H, Lobisch M, Schütte K, Kerum G, et al. (1999). Treatment of symptomatic diabetic polyneuropathy with the antioxidant alpha-lipoic acid: a 7-month multicenter randomized controlled trial (ALADIN III Study). ALADIN III Study Group. Diabetes Care. (Among 509 patients with diabetic neuropathy treated with ALA [600 mg] or placebo intravenously for 3 weeks followed by ALA [600 mg] or placebo 3 times daily for 6 months, there were no differences in symptoms of peripheral neuropathy among the 3 groups; adverse events rates were similar in the 3 groups and no mention of ALT elevations or hepatotoxicity).
Ametov AS, Barinov A, Dyck PJ, Hermann R, Kozlova N, Litchy WJ, Low PA, et al., SYDNEY Trial Study Group. (2003). The sensory symptoms of diabetic polyneuropathy are improved with alpha-lipoic acid: the SYDNEY trial. Diabetes Care. (Among 120 patients with diabetic neuropathy treated with ALA [600 mg] or placebo intravenously 5 days a week for 14 weeks, symptoms improved more in the ALA treated group, particularly during the final month while rates of side effects were similar in the two groups and “no adverse event was judged to be causally related to the trial medication”).
Packer L, Kraemer K, Rimbach G. (2001). Molecular aspects of lipoic acid in the prevention of diabetes complications. Nutrition. (Review of the biochemistry and pharmacology of alpha lipoic acid focusing upon differences in update and activity of the two enantiomers of ALA, R and S, and the antioxidant effects of R-ALA and mechanism of action in diabetes, polyneuropathy and vascular physiology).
Cremer DR, Rabeler R, Roberts A, Lynch B. (2006). Safety evaluation of alpha-lipoic acid (ALA). Regul Toxicol Pharmacol. (Evaluation of the safety of oral ALA in rats who exhibited no evidence of toxicity except at the highest doses tested [121 mg/kg], which was associated with minor ALT elevations in males and slight changes in liver histology including small droplet fat in periportal regions, but without frank hepatocyte necrosis or inflammation).
Shay KP, Moreau RF, Smith EJ, Smith AR, Hagen TM. (2009). Alpha-lipoic acid as a dietary supplement: molecular mechanisms and therapeutic potential. Biochim Biophys Acta. (Extensive review of the biochemistry of ALA and the basis for its suspected antioxidant activities and their possible role in diabetes and polyneuropathy).
Solmonson A, DeBerardinis RJ. (2018). Lipoic acid metabolism and mitochondrial redox regulation. J Biol Chem. (Biochemistry of ALA and review of its role in mitochondrial pathways of energy metabolism).
Cameron M, Taylor C, Lapidus J, Ramsey K, Koop D, Spain R. (2020). Gastrointestinal tolerability and absorption of R- versus R,S-lipoic acid in progressive multiple sclerosis: a randomized crossover trial. J Clin Pharmacol. (Among 20 adults with multiple sclerosis given either 600 mg of an R enantiomer of ALA or 1200 mg of a racemic mixture of the R and S enantiomers for 7 days and then crossed over to the other dosage, absorption and ALA[R] plasma concentration areas under the curve were similar for the 2 forms but gastrointestinal side effects were greater with the 1200 mg dosage; no mention of ALT levels or hepatotoxicity).
Ziegler D, Ametov A, Barinov A, Dyck PJ, Gurieva I, Low PA, Munzel U, Yakhno N, Raz I, Novosadova M, Maus J, Samigullin R. (2006). Oral treatment with alpha-lipoic acid improves symptomatic diabetic polyneuropathy: the SYDNEY 2 trial. Diabetes Care. (Among 181 diabetic patients with sensorimotor polyneuropathy in Russia and Israel treated with ALA [600, 12000 and 1800 mg] or placebo daily for 5 weeks, symptoms improved more with all 3 doses of ALA compared to placebo [by 48%-52% vs 32%], while adverse events that were more frequent with higher doses of ALA included nausea, vomiting and vertigo).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list alpha lipoic acid among products associated with 5 or more reports).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not ALA).
Ziegler D, Low PA, Litchy WJ, Boulton AJ, Vinik AI, Freeman R, Samigullin R, et al. (2011). Efficacy and safety of antioxidant treatment with α-lipoic acid over 4 years in diabetic polyneuropathy: the NATHAN 1 trial. Diabetes Care. (Among 460 patients with diabetic polyneuropathy treated with ALA [600 mg] or placebo once daily for 4 years, there were no differences in the primary outcomes between the two treatment groups while severe adverse events were more frequent with ALA [38% vs 28%]; no mention of ALT levels or hepatotoxicity).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not mention or list alpha lipoic acid).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention alpha lipoic acid).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies, but does not mention ALA).
Leung PS, Wang J, Naiyanetr P, Kenny TP, Lam KS, Kurth MJ, Gershwin ME. (2013). Environment and primary biliary cirrhosis: electrophilic drugs and the induction of AMA. J Autoimmun. (The antimitochondrial antibody of primary biliary cirrhosis binds to the lipoic acid moiety of the E2 domain of pyruvate dehydrogenase and effectively blocks the activity of the enzyme).
Karaarslan U, İşgüder R, Bağ Ö, Kışla M, Ağın H, Ünal N. (2013). Alpha lipoic acid intoxication, treatment and outcome. Clin Toxicol (Phila). (20 month old boy ingested 4 tablets of ALA [2400 mg] belonging to a patient with diabetes in his home and was admitted 4 hours later with status epilepticus, metabolic acidosis [pH 7.2, lactate 3.9 mmoL] but normal ALT and AST, and resolving within 48 hours with supportive care).
Emir DF, Ozturan IU, Yilmaz S. (2018). Alpha lipoic acid intoxication: an adult. Am J Emerg Med. (A 22 year old woman took an overdose of ALA [18,000 mg] and was found to be confused with severe metabolic acidosis [pH 7.22, lactate 76 mg/dL, ALT 11 U/L, AST 19 U/L, platelets 209,000 falling to 140,000/µL], was treated with gastric lavage, charcoal administration and hydration and recovered within 3 days).
Gulen M, Simsek Y, Oner E, Satar S. (2018). First description of the alpha lipoic acid intoxication in an adult patient worldwide following oral administration. Am J Emerg Med. (38 year old woman took an intentional overdose of ALA [6000 mg] and rapidly developed delirium and metabolic acidosis, thrombocytopenia and rhabdomyolysis [pH 7.26, CPK 174 rising to 5,229 U/L 24 hours later, creatinine 0.84 to 0.93 mg/dL, ALT 17 to 33 U/L, AST 20 to 119 U/L, platelets 189,000 to 64,000/µL, INR 1.24 to 1.4], was treated with supportive care and recovered within 3 days).
Hadzik B, Grass H, Mayatepek E, Daldrup T, Hoehn T. (2014). Fatal non-accidental alpha-lipoic acid intoxication in an adolescent girl. Klin Padiatr. (14 year old girl took an intentional overdose of 10 tablets of ALA [6000 mg] and rapidly developed convulsions with metabolic acidosis [pH 6.5, lactate 24 mmoL] progressing to multiorgan failure and dying within 19 hours of admission [platelets 114,000 to 12,000/µL, INR 2.8 to 6 .0, creatinine 1.2 to 2.2 mg/dL, CK 1,059 to 18,383 U/L, ALT 43 to 76 U/L]).
Tolunay O, Çelik T, Kömür M, Gezgin AE, Kaya MS, Çelik Ü. (2015). A rare cause of status epilepticus; alpha lipoic acid intoxication, case report and review of the literature. Eur J Paediatr Neurol. (14 month old female developed seizures shortly after ingestion of ALA tablets [belonging to a family member] and was admitted with myoclonus unresponsive to benzodiazepines and metabolic acidosis [pH 7.24, ALT 22 U/L, CK 231 U/L], resolving with supportive care within 2-3 days).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to alpha lipoic acid).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss alpha lipoic acid).
Moretti R, Angeletti C, Minora S. (2019). Multiple organ failure and shock following acute alpha lipoic acid (ALA) intoxication. Clin Toxicol (Phila). (70 year old woman developed seizures within 30 minutes after mistakenly taking an industrial form of ALA [4500 mg] with metabolic acidosis, lactic acidosis [14.9 mmoL], decrease in platelets [140,000 decreasing to 73,000/uL], and hemodynamic instability, responding to supportive therapy within several days).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of alpha lipoic acid).
Rahmanabadi A, Mahboob S, Amirkhizi F, Hosseinpour-Arjmand S, Ebrahimi-Mameghani M. (2019). Oral α-lipoic acid supplementation in patients with non-alcoholic fatty liver disease: effects on adipokines and liver histology features. Food Funct. (Among 50 Iranian patients with nonalcoholic fatty liver disease treated with ALA [600 mg] or placebo twice daily for 12 weeks, changes in serum ALT and AST, body weight and the intensity of hepatic steatosis did not differ in the two treatment arms, although measures of insulin sensitivity and adiponectin levels improved more with ALA treatment).
Hosseinpour-Arjmand S, Amirkhizi F, Ebrahimi-Mameghani M. (2019). The effect of alpha-lipoic acid on inflammatory markers and body composition in obese patients with non-alcoholic fatty liver disease: A randomized, double-blind, placebo-controlled trial. J Clin Pharm Ther. (Among 50 obese Iranian adults with nonalcoholic fatty liver disease treated with vitamin E [400 IU] with or without alpha lipoic acid [1200 mg] daily for 12 weeks, serum ALT and AST improved to a similar extent in both groups as did hepatic steatosis, while adiponectin levels increased and insulin and IL-6 levels decreased more in the ALA treated patients; no mention of adverse events).
Dumitru E, Condur L, Alexandrescu L, Chirila S, Greere M, Radu C, Tabacelia D, et al. (2020). Triple antioxidant therapy, an alternative for patients with chronic liver disease – a prospective multicenter interventional study. Maedica (Bucur). (Among 1718 adults with nonalcoholic fatty liver treated with a fixed combination of selenium, silymarin and alpha lipoic acid [doses not provided] for at least 24 weeks, hepatic steatosis resolved in 9% and improved in another 59% of patients, while serum ALT fell to normal in 29% of those with elevated values at baseline; no mention of adverse events).
Gilron I, Robb S, Tu D, Holden R, Towheed T, Ziegler D, Wang L, et al. (2021). Double-blind, randomized, placebo-controlled crossover trial of alpha-lipoic acid for the treatment of fibromyalgia pain: the IMPALA trial. Pain. (Among 27 patients with fibromyalgia treated in a cross over trial of 5 week courses of ALA [600 mg daily] or placebo, symptoms of fibromyalgia and quality of life were similar in both treatment groups, as were adverse event rates).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; alpha lipoic acid was not listed among the 79 implicated products).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while alpha lipoic acid was not mentioned).
Ziegler D, Tesfaye S, Spallone V, Gurieva I, Al Kaabi J, Mankovsky B, Martinka E, et al. (2022). Screening, diagnosis and management of diabetic sensorimotor polyneuropathy in clinical practice: International expert consensus recommendations. Diabetes Res Clin Pract. (Expert consensus recommendations for diagnosis and management of diabetic neuropathy).
Ahmadi M, Keshavarz SA, Abbasi B. (2022). Effects of alpha lipoic acid supplementation on serum lipid profile in patients with metabolic syndrome: A randomized, double-blind, placebo-controlled clinical trial. ARYA Atheroscler. (Among 46 Iranian patients with the metabolic syndrome treated with ALA [600 mg] or placebo once weekly for 12 weeks, treatment with ALA compared to placebo was associated with significant changes in triglyceride levels [-37 vs +6 mg/dL] and total cholesterol levels [-9 vs + 11 mg/dL] but not in HDL or LDL cholesterol levels; no mention of ALT levels or hepatotoxicity).
Halabi Z, El Helou C, Al Balushi H, Gittinger M, Steck AR, Kaakour A, Abu-Alfa A, et al. (2023). Alpha lipoic acid toxicity: the first reported mortality in an adult patient after multiorgan failure. J Emerg Med. (42 year old woman presented 4 hours after an intentional overdose of 6000 mg of ALA and 7.5 gm of acetaminophen with refractory seizures, metabolic acidosis [pH 7.29, lactate 8.79 mmoL], with progressive multiple organ failure and cardiac arrhythmias resulting in death within 26 hours [CPK 848 rising to 14,447 U/L, ALT 15 to 53 U/L, AST 15 to 122 U/L, INR 1.1 to 3.0, creatinine 0.6 to 3.4]).

## OTHER REFERENCE LINKS

1 Recent References on Alpha Lipoic Acid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Alpha+Lipoic+Acid+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Alpha Lipoic Acid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alpha%20Lipoic%20Acid)